# Gemtuzumab Ozogamicin

## OVERVIEW

### Introduction

Gemtuzumab ozogamicin is a humanized monoclonal antibody conjugate that is used in the therapy of acute myelogenous leukemia. Gemtuzumab ozogamicin has been linked to transient serum enzyme elevations during therapy and not uncommon instances of acute sinusoidal obstruction syndrome, which can be severe and even fatal.

### Background

Gemtuzumab (jem tooz’ ue mab) ozogamicin (oh” zoe ga mye’ sin) is a humanized monoclonal IgG4 antibody to the human CD33 cell surface marker that is highly expressed on acute myelogenous leukemia cells. The monoclonal antibody is conjugated using a linker sequence to a cytotoxic molecule, ozogamicin (N-acetyl gamma calicheamicin). When gemtuzumab binds to CD33, it is internalized and the ozogamicin is released by the action of lysosomal enzymes on the linker molecule that joins the monoclonal antibody to the cytotoxic molecule. The intracellular ozogamicin binds to cellular DNA and causes double-stranded DNA breaks resulting in apoptotic cell death. This monoclonal antibody conjugate was shown to be effective in inducing remissions in refractory, CD33 positive acute myelogenous leukemia in patients over the age of 60 years and was given accelerated approval for this indication in the United States in 2000. A subsequent randomized controlled trial, however, showed that the mortality rate was higher with gemtuzumab ozogamicin than with conventional therapy and the monoclonal antibody conjugate was withdrawn from use in 2010. Further studies suggested that a modified dosing schedule (total of 9 mg/m^2^ given over days 1 and 4 or days 1, 4 and 7) was effective in prolonging event-free survival in patients with acute myelogenous leukemia and had a lower rate of severe hepatic injury than regimens using the 9 mg/m^2^ dose given over one day. Accordingly, gemtuzumab ozogamicin was approved and reintroduced as a therapy of CD33 positive acute myelogenous leukemia in 2017. Current indications are for both adults and children with de novo or refractory/relapsed acute myelogenous leukemia. Gemtuzumab ozogamicin is available in powder for reconstitution in single dose vials of 4.5 mg under the brand name Mylotarg. Gemtuzumab ozogamicin can be given by itself or in combination with daunorubicin and cytarabine. The typical recommended dose regimen for induction is 3 mg/m^2^ on days 1, 4 and 7 by intravenous infusion over 2 hours, but recommended dosing varies by indication, whether for induction or maintenance treatment, and by whether it is given alone or in combination with other antineoplastic agents. Common side effects include infusion reactions with fever, nausea, chills, hypotension and shortness of breath and subsequent adverse events of hemorrhage, infection, fever, nausea and vomiting, constipation, anorexia, fatigue, headache, rash, mucositis, neutropenia and thrombocytopenia. Less common, but serious side effects include anaphylactic reactions, severe neutropenia, infections, hemorrhage, and acute hepatic failure. Gemtuzumab ozogamicin should be administered only by physicians and health care providers with training and expertise in cancer chemotherapy and management of its potential adverse effects.

### Hepatotoxicity

In initial publications on trials of gemtuzumab ozogamicin, up to half of patients had serum ALT or AST elevations during therapy that were greater than 5 times the upper limit of normal (ULN) in 10% to 16%. Hyperbilirubinemia was also common during gemtuzumab therapy. More importantly, a variable proportion (ranging from 2% to 35%) of patients developed clinically apparent sinusoidal obstruction syndrome (SOS). Symptoms of nausea, right upper quadrant pain, weight gain and abdominal distension (from ascites) arose within 5 to 20 days of the infusion and were followed by progressive rise in serum bilirubin, aminotransferase and alkaline phosphatase levels. Recent studies using lower and fractionated regimens of administration of gemtuzumab ozogamicin have reported rates of sinusoidal obstruction syndrome of 1% to 5% compared to <1% with standard chemotherapy. In general, SOS that is severe enough to cause clinical symptoms and signs has an extremely poor prognosis, with a mortality rate as high as 70%, most patients dying of multiorgan failure. Risk factors for developing SOS after gemtuzumab ozogamicin therapy include allogenic hematopoietic cell transplantation, use of other antineoplastic agents, and presence of preexisting liver disease. There are no proven means of prevention or treatment of SOS due to gemtuzumab ozogamicin, although pretreatment with ursodiol and acute management with defibrotide are often employed.

Likelihood score: A (well known cause of clinically significant liver injury, typically the result of sinusoidal obstruction syndrome).

### Mechanism of Injury

The cause of the serum enzyme elevations during gemtuzumab ozogamicin therapy is not known, but it is likely due to direct toxicity of the conjugated ozogamicin. The propensity of gemtuzumab ozogamicin to cause sinusoidal obstruction syndrome is perhaps due to the fact that hepatic sinusoidal endothelial cells express CD33 on the cell surface and the antibody conjugate may be taken up by these cells, resulting in their damage and release of apoptotic fragments into sinusoids causing pro-inflammatory and pro-fibrotic reactions and sinusoidal obstruction.

### Outcome and Management

The product label of gemtuzumab includes a boxed warning of hepatic injury and sinusoidal obstruction syndrome and recommends monitoring of serum enzymes and bilirubin before each dose as well as clinical monitoring for signs and symptoms of sinusoid obstruction syndrome during therapy. The serum aminotransferase elevations that occur during low dose, fractionated gemtuzumab ozogamicin therapy are usually transient, mild and asymptomatic and do not require dose modification or delay in therapy. Serum aminotransferase elevations above 5 times the upper limit of normal or elevations in serum bilirubin should lead to more careful monitoring and suspension of further infusions, at least until levels return to normal or near normal levels. If patients develop symptoms, signs, or laboratory evidence of sinusoidal obstruction syndrome, therapy should be discontinued and patients carefully monitored.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

Other Monoclonal Antibody Conjugates: Ado-Trastuzumab Emtansine, Benlantamab Mafodotin, Brentuximab Vedotin, Enfortumab Vedotin, Inotuzumab Ozogamicin, Polatuzumab Vedotin, Sacituzumab Govitecan, Tisotumab Vedotin, Trastuzumab Deruxtecan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Gemtuzumab Ozogamicin – Mylotarg®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Gemtuzumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Gemtuzumab Ozogamicin | 356547-88-1 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 November 2023

Abbreviations used: AML, acute myelogenous leukemia; OD, odds ratio; SOS, sinusoidal obstruction syndrome; HCT, hematopoietic cell transplantation.

DeLeve LD. Gemtuzumab ozogamicin. Liver sinusoidal endothelial cells and liver injury. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 142-3. (Review of agents that damage liver sinusoidal cells, including gemtuzumab ozogamicin, mentions that CD33 which is present on leukemic blast cells is also present on liver sinusoidal endothelial cells).
Chabner BA, Barnes J, Neal J, Olson E, Mujagiv H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
Gemtuzumab for relapsed acute myeloid leukemia. Med Lett Drugs Ther 2000; 42: 67-8. (Concise review of the mechanism of action, efficacy and safety of gemtuzumab in acute myeloid leukemia [AML]; mentions that it has been associated with hyperbilirubinemia, serum enzyme elevations and one case of hepatic failure). 10908423
Neumeister P, Eibl M, Zinke-Cerwenka W, Scarpatetti M, Sill H, Linkesch W. Hepatic veno-occlusive disease in two patients with relapsed acute myeloid leukemia treated with anti-CD33 calicheamicin (CMA-676) immunoconjugate. Ann Hematol 2001; 80: 119-20. (2 patients with sinusoidal obstruction syndrome [SOS] after an initial dose of gemtuzumab ozogamicin; a 50 year old man with refractory AML developed jaundice 2 weeks after a single infusion [bilirubin 27 mg/dL], with hepatomegaly and ascites dying 2 weeks later; and, a 45 year old woman with refractory AML developed jaundice 8 days after initial infusion [bilirubin 32 mg/dL], with ascites, renal failure and death 4 weeks later). 11261323
Bross PF, Beitz J, Chen G, Chen XH, Duffy E, Kieffer L, Roy S, et al. Approval summary: gemtuzumab ozogamicin in relapsed acute myeloid leukemia. Clin Cancer Res 2001; 7: 1490-6. (Review of the preclinical and clinical trials of gemtuzumab ozogamicin for refractory AML that formed the basis of its accelerated approval by the FDA, mentions that 45 of 142 patients developed severe liver test abnormalities, 12 of whom had elevations in both bilirubin and ALT). 11410481
Giles FJ, Kantarjian HM, Kornblau SM, Thomas DA, Garcia-Manero G, Waddelow TA, David CL, et al. Mylotarg (gemtuzumab ozogamicin) therapy is associated with hepatic venoocclusive disease in patients who have not received stem cell transplantation. Cancer 2001; 92: 406-13. (Among 119 patients with AML treated with gemtuzumab ozogamicin, 14 [12%] developed SOS with abrupt onset of weight gain, abdominal distension and pain [bilirubin 2.2-33.6 mg/dL, peak ALT 43-1789 U/L], being a major cause of death in 5, and probably contributory in 3 and possibly in 4 more patients). 11466696
Tack DK, Letendre L, Kamath PS, Tefferi A. Development of hepatic veno-occlusive disease after Mylotarg infusion for relapsed acute myeloid leukemia. Bone Marrow Transplant 2001; 28: 895-7. (67 year old woman with refractory AML after hematopoietic cell transplantation [HCT] developed SOS arising 6 days after intravenous gemtuzumab ozogamicin, with ascites and jaundice [peak bilirubin 15.8 mg/dL]). 11781652
Gordon LI. Gemtuzumab Ozogamicin (Mylotarg) and hepatic veno-occlusive disease: take two acetaminophen, and. Bone Marrow Transplant 2001; 28: 811-2. (Editorial in response to Tack [2001] reviewing the pathogenesis of SOS and the possible role of free radicals and potential for acetaminophen to contribute to the injury). 11781639
Rajvanshi P, Shulman HM, Sievers EL, McDonald GB. Hepatic sinusoidal obstruction after gemtuzumab ozogamicin (Mylotarg) therapy. Blood 2002; 99: 2310-4. (Among 23 patients with relapsed, refractory AML treated with gemtuzumab ozogamicin, liver injury suggestive of SOS developed in 11, 7 of whom died of hepatic failure 8 to 47 days after the infusion). 11895761
Leopold LH, Berger MS, Feingold J. Acute and long-term toxicities associated with gemtuzumab ozogamicin (Mylotarg) therapy of acute myeloid leukemia. Clin Lymphoma 2002; 2 Suppl 1: S29-34. (Review of adverse side effects of gemtuzumab ozogamicin therapy mentions mild ALT and AST [Grade 1 and 2] elevations in 26% and elevations ≥5 times ULN in 16% and clinically apparent SOS in 2-12% of patients, risk factors for this complication being HCT, concurrent cytotoxic therapies, higher and more frequent doses and underlying liver disease). 11970768
McDonald GB. Management of hepatic sinusoidal obstruction syndrome following treatment with gemtuzumab ozogamicin (Mylotarg). Clin Lymphoma 2002; 2 Suppl 1: S35-9. (Review of management of SOS). 11970769
Giles F, Garcia-Manero G, Cortes J, Thomas D, Kantarjian H, Estey E. Ursodiol does not prevent hepatic venoocclusive disease associated with Mylotarg therapy. Haematologica 2002; 87: 1114-6. (Among 85 patients with refractory AML or myelodysplastic syndromes treated with gemtuzumab ozogamicin and given ursodiol starting the day before infusion and continuing for 21 days, ten [12%] developed SOS, a rate similar to that reported before use of ursodiol [Giles 2001]). 12368170
O'Boyle KP, Murigeppa A, Jain D, Dauber L, Dutcher JP, Wiernik PH. Probable veno-occlusive disease after treatment with gemtuzumab ozogamicin in a patient with acute myeloid leukemia and a history of liver transplantation for familial hemochromatosis. Med Oncol 2003; 20: 379-84. (69 year old man with a history of liver transplantation and AML developed rising AST and bilirubin levels 7 days and died 13 days after an infusion of gemtuzumab ozogamicin). 14716035
Nabhan C, Rundhaugen L, Jatoi M, Riley MB, Boehlke L, Peterson LC, Tallman MS. Gemtuzumab ozogamicin (Mylotarg^TM^) is infrequently associated with sinusoidal obstructive syndrome/veno-occlusive disease. Ann Oncol 2004; 15: 1231-6. (Among 47 patients with AML treated with gemtuzumab as a single agent, 23 [48%] had elevation of liver tests, but only one [2%] developed clinically apparent SOS). 15277263
Amadori S, Suciu S, Willemze R, Mandelli F, Selleslag D, Stauder R, Ho A, et al.; EORTC leukemia group; GIMEMA leukemia group. Sequential administration of gemtuzumab ozogamicin and conventional chemotherapy as first line therapy in elderly patients with acute myeloid leukemia: a phase II study (AML-15) of the EORTC and GIMEMA leukemia groups. Haematologica 2004; 89: 950-6. (Among 57 patients with AML treated with gemtuzumab ozogamicin on days 1 and 15, severe myelosuppression was universal and SOS occurred in 3, which was fatal in 2 patients). 15339678
Perry R, Penk Kapoor N, Shah AJ, Kapoor N, Shah AJ. Gemtuzumab ozogamicin exposure and portal fibrosis. Pediatr Blood Cancer 2005; 45: 82-3. (An 8 year old girl and 5 year old boy with acute leukemia developed clinical evidence of SOS after several courses of gemtuzumab ozogamicin therapy, and liver biopsies showed periportal fibrosis). 15880448
Arceci RJ, Sande J, Lange B, Shannon K, Franklin J, Hutchinson R, Vik TA, et al. Safety and efficacy of gemtuzumab ozogamicin in pediatric patients with advanced CD33+ acute myeloid leukemia. Blood 2005; 106: 1183-8. (Among 29 children with relapsed or refractory AML treated with gemtuzumab ozogamicin, 21% developed ALT or AST elevations and one SOS). 15886328
Larson RA, Sievers EL, Stadtmauer EA, Löwenberg B, Estey EH, Dombret H, Theobald M, et al. Final report of the efficacy and safety of gemtuzumab ozogamicin (Mylotarg) in patients with CD33-positive acute myeloid leukemia in first recurrence. Cancer 2005; 104: 1442-52. (277 patients with relapsed AML treated with gemtuzumab ozogamicin, 28% developed ALT levels ≥5 times ULN and 29% bilirubin levels ≥3 times ULN and 0.9% SOS). 16116598
Lannoy D, Decaudin B, Grozieux de Laguérenne A, Barrier F, Pignon JM, Wetterwald M, et al. Gemtuzumab ozogamicin-induced sinusoidal obstructive syndrome treated with defibrotide: a case report. J Clin Pharm Ther 2006; 31: 389-92. (65 year old man with AML treated with gemtuzumab ozogamicin developed SOS 23 days after the first dose and died of multiorgan failure several weeks later despite therapy with defibrotide). 16882110
McKoy JM, Angelotta C, Bennett CL, Tallman MS, Wadleigh M, Evens AM, Kuzel TM, et al. Gemtuzumab ozogamicin-associated sinusoidal obstructive syndrome (SOS): an overview from the research on adverse drug events and reports (RADAR) project. Leuk Res 2007; 31: 599-604. (Analysis of the FDAs MedWatch database revealed 99 reports of SOS in adult and 6 in pediatric patients treated with gemtuzumab ozogamicin; review of clinical trials and observational studied found highest rates of SOS [14-40%] in patients who underwent HCT within 3 months of receiving gemtuzumab or who received concurrent chemotherapy with potentially hepatotoxic agents). 16959316
Maradei SC, Maiolino A, de Azevedo AM, Colares M, Bouzas LF, Nucci M. Serum ferritin as risk factor for sinusoidal obstruction syndrome of the liver in patients undergoing hematopoietic stem cell transplantation. Blood 2009; 114: 1270-5. (Among 427 patients undergoing HCT, 88 [21%] developed SOS of whom 57 [65%] died; risk factors being allogenic HCT [33%], receipt of imatinib [52%], busulfan [39%], and ferritin above 2000 ng/mL [34%]; only one patient received gemtuzumab). 19401560
Zwaan CM, Reinhardt D, Zimmerman M, Hasle H, Stary J, Stark B, Dworzak M, et al.; International BFM Study Group on Paediatric AML. Salvage treatment for children with refractory first or second relapse of acute myeloid leukaemia with gemtuzumab ozogamicin: results of a phase II study. Br J Haematol 2010; 148: 768-76. (Among 30 children with refractory or relapsing AML treated with gemtuzumab ozogamicin, "treatment was generally well tolerated", only 19 [63%] had ALT or AST elevations which were ≥5 times ULN in 2 [7%], and none developed SOS). 19995399
Chevallier P, Prebet T, Turlure P, Hunault M, Vigouroux S, Harousseau JL, Blaise D, et al. Prior treatment with gemtuzumab ozogamicin and the risk of veno-occlusive disease after allogeneic haematopoietic stem cell transplantation. Bone Marrow Transplant 2010; 45: 165-70. (Among 44 adults with AML treated gemtuzumab ozogamicin followed by HCT, 3 [7%] developed SOS). 19584826
Löwenberg B, Beck J, Graux C, van Putten W, Schouten HC, Verdonck LF, Ferrant A, et al.; Dutch-Belgian Hemato-Oncology Cooperative Group (HOVON); German Austrian AML Study Group (AMLSG); Swiss Group for Clinical Cancer Research Collaborative Group (SAKK). Gemtuzumab ozogamicin as postremission treatment in AML at 60 years of age or more: results of a multicenter phase 3 study. Blood 2010; 115: 2586-91. (Randomized trial of gemtuzumab ozogamicin vs placebo in patients with AML after remission, found overall survival was not improved by the monoclonal conjugate [17% vs 16% at 5 years] and 17% had moderate-to-severe hepatic side effects, one patient dying of SOS during the first course of therapy). 20103782
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 2 attributed to antineoplastic agents, 1 due to melphalan and 1 to gemtuzumab ozogamicin). 20949552
Maniecki MB, Hasle H, Bendix K, Møller HJ. Is hepatotoxicity in patients treated with gemtuzumab ozogamicin due to specific targeting of hepatocytes? Leuk Res 2011; 35: e84-6. (Immunohistochemical staining of liver tissue showed that both hepatocytes and macrophages [Kupffer cells] express CD33). 21329979
Malfuson JV, Konopacki J, Thepenier C, Eddou H, Foissaud V, de Revel T. Fractionated doses of gemtuzumab ozogamicin combined with 3 + 7 induction chemotherapy as salvage treatment for young patients with acute myeloid leukemia in first relapse. Ann Hematol 2012; 91: 1871-7. (Among 14 patients with relapsed AML treated with fractionated doses of gemtuzumab ozogamicin [3 mg/m2 given on days 1, 4 and 7:], 11 had a response and underwent HCT, of whom 4 subsequently developed nonfatal SOS, all resolving with conservative management). 22820971
Castaigne S, Pautas C, Terré C, Raffoux E, Bordessoule D, Bastie JN, Legrand O, et al.; Acute Leukemia French Association. Effect of gemtuzumab ozogamicin on survival of adult patients with de-novo acute myeloid leukaemia (ALFA-0701): a randomised, open-label, phase 3 study. Lancet 2012; 379 (9825): 1508-16. (Among 280 patients with previously untreated AML given standard chemotherapy with or without gemtuzumab ozogamicin, grade 3 hepatic adverse events occurred in 6% of standard vs 13% of gemtuzumab treated subjects and SOS occurred in 3 subjects, being fatal in 2). 22482940
Iacobucci I, Lonetti A, Candoni A, Sazzini M, Papayannidis C, Formica S, Ottaviani E, et al. Profiling of drug-metabolizing enzymes/transporters in CD33+ acute myeloid leukemia patients treated with gemtuzumab-ozogamicin and fludarabine, cytarabine and idarubicin. Pharmacogenomics J 2013; 13: 335-41. (Analysis of 1931 single nucleotide variants in 225 drug metabolizing enzyme or transporter genes in 95 patients with AML undergoing chemotherapy with gemtuzumab ozogamicin combined with other agents identified several variants associated with a higher or lower risk of hepatotoxicity). 22584460
Amadori S, Suciu S, Stasi R, Salih HR, Selleslag D, Muus P, De Fabritiis P, et al. Sequential combination of gemtuzumab ozogamicin and standard chemotherapy in older patients with newly diagnosed acute myeloid leukemia: results of a randomized phase III trial by the EORTC and GIMEMA consortium (AML-17). J Clin Oncol 2013; 31: 4424-30. (Among 472 patients with AML, addition of a course of gemtuzumab ozogamicin before standard chemotherapy resulted in no improvement in overall response rates, but was associated with higher early mortality some of which was due to SOS). 24127442
Kharfan-Dabaja MA, Hamadani M, Reljic T, Pyngolil R, Komrokji RS, Lancet JE, Fernandez HF, et al. Gemtuzumab ozogamicin for treatment of newly diagnosed acute myeloid leukaemia: a systematic review and meta-analysis. Br J Haematol 2013; 163: 315-25. (Systematic review and metaanalysis of 7 controlled trials of gemtuzumab ozogamicin in 3942 patients found no increase in overall survival and a higher rate of early mortality [relative risk, RR =1.6] and SOS [RR=7.7]). 24033280
Tallman MS, McDonald GB, DeLeve LD, Baer MR, Cook MN, Graepel GJ, Kollmer C. Incidence of sinusoidal obstruction syndrome following Mylotarg(gemtuzumab ozogamicin): a prospective observational study of 482 patients in routine clinical practice. Int J Hematol 2013; 97: 456-64. (Among 482 patients with AML treated with gemtuzumab ozogamicin in multiple clinical practices, 44 [9%] developed SOS of whom 13 [3%] died of resultant multiorgan failure). 23460018
de Witte T, Suciu S, Meert L, Halkes C, Selleslag D, Bron D, Amadori S, et al. Idarubicin and cytarabine in combination with gemtuzumab ozogamicin (IAGO) for untreated patients with high-risk MDS or AML evolved from MDS: a phase II study from the EORTC and GIMEMA Leukemia Groups (protocol 06013). Ann Hematol 2015; 94: 1981-9. (Among 30 patients with high risk myelodysplastic syndromes or AML treated with idarubicin, cytarabine and gemtuzumab ozogamicin [one dose, 5 mg/m^2^], ALT elevations above 5 times ULN arose in 16 [53%] and one patient had nonfatal SOS). 26410352
Koren-Michowitz M, Maayan H, Apel A, Shem-Tov N, Yerushalmi R, Volchek Y, Avigdor A, et al. Salvage therapy with ARA-C and gemtuzumab ozogamicin in AML patients relapsing after stem cell transplantation. Ann Hematol 2015; 94: 375-8. (Among 16 patients with AML who relapsed after HCT and were treated with cytarabine and gemtuzumab ozogamicin, serum enzyme elevations occurred in 80% and were above 5 times ULN in 27%, with mild SOS occurring in 3 subjects after repeat HCT). 25307457
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5.5%] were attributed to antineoplastic agents, but none were linked to use of gemtuzumab ozogamicin). 25754159
Battipaglia G, Labopin M, Candoni A, Fanin R, El Cheikh J, Blaise D, Michallet M, et al. Risk of sinusoidal obstruction syndrome in allogeneic stem cell transplantation after prior gemtuzumab ozogamicin treatment: a retrospective study from the Acute Leukemia Working Party of the EBMT. Bone Marrow Transplant 2017; 52: 592-9. (Among 146 adults with AML who received gemtuzumab ozogamicin and underwent HCT, 11 [8%] developed SOS which was fatal in 3 [2%]). 28092357
Jen EY, Ko CW, Lee JE, Del Valle PL, Aydanian A, Jewell C, Norsworthy KJ, et al. FDA approval: gemtuzumab ozogamicin for the treatment of adults with newly diagnosed CD33-positive acute myeloid leukemia. Clin Cancer Res. 2018;24:3242-3246. (Summary of the data on safety and efficacy of gemtuzumab ozogamicin as therapy of newly diagnosed CD33-positive AML based upon a randomized controlled trial in 271 patients receiving daunorubicin and cytarabine with or without gemtuzumab ozogamicin in which toxicities did not differ significantly between treatment arms, liver dysfunction arising in 4% of both). 29476018
Norsworthy KJ, Ko CW, Lee JE, Liu J, John CS, Przepiorka D, Farrell AT, Pazdur R. FDA approval summary: Mylotarg for treatment of patients with relapsed or refractory CD33-positive acute myeloid leukemia. Oncologist. 2018;23:1103-1108. (Summary of the data on safety and efficacy of gemtuzumab ozogamicin as therapy of relapsed or refractory CD33-positive AML which led to the FDA reapproval of this agent for this indication and de novo AML [Jen et al 2018], in trials of lower dose, fractionated regimens of gemtuzumab ozogamicin [3 mg/m^2^ on days 1, 4 and 7]; among 87 patients treated with this regimen, 16% had ALT elevations but none were above 5 times ULN and there were no cases of SoS). 29650683
Short NJ, Rytting ME, Cortes JE. Acute myeloid leukaemia. Lancet. 2018;392(10147):593-606. (Review of the epidemiology, pathogenesis, risk stratification, diagnosis, and treatment of AML, including regimens for de novo as well as relapsed or refractory cases). 30078459
Lambert J, Pautas C, Terré C, Raffoux E, Turlure P, Caillot D, Legrand O, et al. Gemtuzumab ozogamicin for de novo acute myeloid leukemia: final efficacy and safety updates from the open-label, phase III ALFA-0701 trial. Haematologica. 2019;104:113-119. (Among 271 patients with de novo AML treated with daunorubicin and cytarabine with or without gemtuzumab ozogamicin, event-free survival was 17.3 vs 9.5 months and overall survival 27.5 vs 21.8 months, SOS arising in 6 [4.5%: 1 case fatal] vs none, and discontinuation for hepatobiliary adverse events arising in 8 [6.1%] vs 1 [0.7%]). 30076173
Ali S, Dunmore HM, Karres D, Hay JL, Salmonsson T, Gisselbrecht C, Sarac SB, et al. The EMA review of Mylotarg (gemtuzumab ozogamicin) for the treatment of acute myeloid leukemia. Oncologist. 2019;24:e171-e179. (Summary of the data on safety and efficacy of gemtuzumab ozogamicin for treatment of AML by the European Medicines Agency [EMA] showing an improvement in event-free survival in a randomized controlled trial and a metaanalysis of 52 trials; most frequent adverse reactions leading to discontinuation were thrombocytopenia, SOS, hemorrhage, and infection, SOS arising in 6 of 131 patients [4.6%], two of whom died and resulting in a higher 30-day mortality [3.8% vs 2.2%] and higher discontinuation rates [31% vs 7%] with gemtuzumab). 30898889
Roeker LE, Kim HT, Glotzbecker B, Nageshwar P, Nikiforow S, Koreth J, Armand P, et al. Early clinical predictors of hepatic veno-occlusive disease/sinusoidal obstruction syndrome after myeloablative stem cell transplantation. Biol Blood Marrow Transplant. 2019;25:137-144. (Among 1853 patients undergoing myeloablative HCT at a single referral center between 1996 and 2015, 205 [11%] developed SOS, the rate decreasing over time from a peak of 18.5% in 2006-2007 to 3% in 2014-2015). 30081073
Corbacioglu S, Jabbour EJ, Mohty M. Risk factors for development of and progression of hepatic veno-occlusive disease/sinusoidal obstruction syndrome. Biol Blood Marrow Transplant. 2019;25:1271-1280. (Review of publications on risk factors for SOS after allogeneic HCT found a strong association with prior treatment with gemtuzumab ozogamicin [odds ratio =20], but recent studies indicate that the incidence of SOS has decreased with use of lower-dose fractionated regimens). 30797942
Schlenk RF, Paschka P, Krzykalla J, Weber D, Kapp-Schwoerer S, Gaidzik VI, Leis C, et al. Gemtuzumab ozogamicin in NPM1-mutated acute myeloid leukemia: early results from the prospective randomized AMLSG 09-09 phase III study. J Clin Oncol. 2020;38:623-632. (Among 581 adults with AML and NPMI mutations treated with idarubicin, cytarabine, etoposide and all-trans retinoic acid with or without gemtuzumab ozogamicin, event-free survival and cumulative mortality were similar in the two treatment arms and, while early death rates were higher, late relapse rates were lower with gemtuzumab ozogamicin). 31851556
Ho VT, Martin AS, Pérez WS, Steinert P, Zhang MJ, Chirnomas D, Hoang CJ, et al. Prior gemtuzumab ozogamicin exposure in adults with acute myeloid leukemia does not increase hepatic veno-occlusive disease risk after allogeneic hematopoietic cell transplantation: a center for international blood and marrow transplant analysis. Biol Blood Marrow Transplant. 2020;26:884-892. (Among 137 patients with a history of gemtuzumab ozogamicin exposure vs 548 non-exposed controls, 5 year survival rates after HCT were similar, SOS was diagnosed in 4% vs 3%, was severe in 3% vs 1% and fatal in 3% vs less than 1%). 31891815
Joubert N, Beck A, Dumontet C, Denevault-Sabourin C. Antibody-drug conjugates: the last decade. Pharmaceuticals (Basel). 2020;13:245. (Review of the development, structure, efficacy, adverse event rates and approval of vector based chemotherapy using selective delivery by a monoclonal antibody and cancer cell injury by a conjugated cellular toxin [payload] including 9 that are FDA approved and 6 others in pivotal trials). 32937862
Ladha A, Mannis G, Muffly L. Hepatic veno-occlusive disease in allogeneic stem cell transplant recipients with prior exposure to gemtuzumab ozogamicin or inotuzumab ozogamicin. Leuk Lymphoma. 2021;62:257-263. (Review of the incidence of SOS after HCT in patients with prior exposure to gemtuzumab ozogamicin or inotuzumab ozogamicin). 32988266
Duncan C, St Martin A, Pérez WS, Steinert P, Zhang MJ, Chirnomas D, Hoang CJ, et al. Veno-occlusive disease risk in pediatric patients with acute myeloid leukemia treated with gemtuzumab ozogamicin before allogeneic hematopoietic cell transplantation. Pediatr Blood Cancer. 2021;68:e29067. (Among 496 children with AML who underwent myeloablative allogeneic HCT between 2008-2011 with [n=148] or without [n=348] prior exposure to gemtuzumab ozogamicin, 5 year survival rates were 51% vs 55%, SOS arose in 16% vs 10%, which was severe in 8% vs 3% and fatal in 3 [2%] vs 1 [<1%] patients). 33871892
Kloehn J, Brodt G, Ernst J, Gruhn B. Analysis of risk factors for hepatic sinusoidal obstruction syndrome following allogeneic hematopoietic stem cell transplantation in pediatric patients. J Cancer Res Clin Oncol. 2022;148:1447-1455. (Among 105 children undergoing allogeneic HCT over a 12 year period at a single referral center in Germany, 15 [14%] developed SOS which was fatal in 3; risk factors for SOS being prior gemtuzumab exposure [OR=11], high serum ferritin levels, and elevated INR). 34255148
Döhner H, Weber D, Krzykalla J, Fiedler W, Kühn MWM, Schroeder T, Mayer K, et al.; German–Austrian AML Study Group. Intensive chemotherapy with or without gemtuzumab ozogamicin in patients with NPM1-mutated acute myeloid leukaemia (AMLSG 09-09): a randomised, open-label, multicentre, phase 3 trial. Lancet Haematol. 2023;10:e495-e509. (Among 588 adults with NPMI-mutated AML treated with idarubicin, cytarabine, etoposide and all-trans retinoic acid with or without gemtuzumab ozogamicin, there were no differences in short and long term survival rates or in hepatoxicity rates [1% in both arms], with one death from hepatotoxicity in the gemtuzumab ozogamicin group). 37187198
Sun C, Yang X, Tang L, Chen J. A pharmacovigilance study on drug-induced liver injury associated with antibody-drug conjugates (ADCs) based on the Food and Drug Administration Adverse Event Reporting System. Expert Opin Drug Saf. 2023 Oct 29:1-12. Epub ahead of print. (Analysis of the FDA reporting system [FAERS] for cases of drug induced liver injury submitted between 2004 and 2022, found 17,784 reports, 504 [3%] attributed to antibody-drug conjugates, 202 from the US, the implicated agents being gemtuzumab ozogamicin [n=98], brentuximab vedotin [n=37], trastuzumab emtansine [n=25], enfortumab vedotin [n=16], inotuzumab ozogamicin [n=15], transtuzumab deruxtecan [n=8], and polatuzumab vedotin [3]). 37898875

## OTHER REFERENCE LINKS

1. Recent References on Gemtuzumab Ozogamicin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Gemtuzumab+AND+Ozogamicin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Gemtuzumab Ozogamicin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Gemtuzumab)